# Flibanserin

## OVERVIEW

### Introduction

Flibanserin is a serotonergic antidepressant used to treat hypoactive sexual desire disorder. Flibanserin has been associated with a low rate of minor serum aminotransferase elevations during treatment, but has not been linked to instances of clinically apparent acute liver injury.

### Background

Flibanserin (flib an' ser in) is a serotonergic mixed agonist and antagonist that was initially developed as an antidepressant when it was found to have possible effects on sexual desire and drive. In vitro, flibanserin acts predominantly as a serotonin (5-HT) 1A receptor agonist, but it also has antagonist activity against other serotonin receptors, such as 5-HT 2C and 2B, as well as less defined activity at dopamine D4 receptors. Flibanserin also has variable regional activities, increasing or decreasing serotonin, dopamine and norepinephrine in different brain areas. While its exact mechanism of action is unclear, flibanserin was found to improve subjective measures of sexual desire and satisfaction in multiple large clinical trials done mostly in premenopausal women who fulfilled the clinical criteria for hypoactive sexual desire disorder. Flibanserin was approved for use in the United States in 2015 for use in treatment of hypoactive sexual desire disorder in premenopausal women. There is limited clinical experience with its use. Concurrent alcohol use is considered contraindicated when taking flibanserin, and caution is recommended against its use with antidepressants or sedatives and in patients wtih hepatic impairment. Flibanserin is available in tablets of 100 mg under the commercial name Addyi. The recommended dose is 100 mg once daily at bedtime. Common side effects include dizziness, fatigue, somnolence, insomnia, nausea and drug mouth. Less common, but potentially serious side effects include hypotension, syncope and next day somnolence or sedation. Because of the severity of these adverse events, flibanserin is available only as a part of a rigorous Risk Evaluation and Mitigration Strategy (REMS) that requires registration, certification of the prescribers and pharmacies, and regular reporting.

### Hepatotoxicity

In placebo controlled trials, liver test abnormalities were no more common with flibanserin than with placebo treatment, and what abnormalities occurred were mild and resolved spontaneously, usually without need for dose interruption. During these premarketing clinical trials and since its more widespread clinical availability, no instances of acute liver injury with jaundice have been reported attributable to flibanserin. However, the total clinical experience with flibanserin use has been limited. Many other serotonergic agents, such as the SSRIs, have been implicated in rare instances of clinically apparent liver injury. The latency to onset is typically 1 to 8 weeks and the pattern of enzyme elevations varies, ranging from cholestatic to hepatocellular. Mild signs and symptoms of hypersensitivity (rash, fever, eosinophilia) are common, but usually not prominent. Autoantibody formation is rare. The course is generally self-limited and mild-to-moderate in severity, but fatalities have been reported with some SSRIs. However, flibanserin itself has not been implicated in similar cases.

Likelihood score: E* (unproven but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which flibanserin might cause serum aminotransferase elevations or liver injury is not known. Flibanserin is metabolized by the liver via the cytochrome P450 system (predominantly CYP 3A4 and 2C19) and is susceptible to drug-drug interactions with agents that induce or inhibit these enzymes. Combination of flibanserin with other serotonergic agents may precipitate the serotonin syndrome marked by fever, tachycardia, hypertension and agitation and can be accompanied by mild serum aminotransferase elevations.

### Outcome and Management

The serum aminotransferase elevations that occur on flibanserin therapy are usually self-limited and do not require dose modification or discontinuation of therapy. No instances of acute liver failure or vanishing bile duct syndrome due to flibanserin have been reported. There is no information on cross sensitivity to liver injury between flibanserin and other antidepressants.

Drug Class: Antidepressant Agents, Serotonergic Agents, Miscellaneous (Agents for Hypoactive Sexual Desire Syndrome)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Flibanserin – Addyi®

DRUG CLASS

Antidepressant Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Flibanserin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Flibanserin | 167933-07-5 | C20-H21-F3-N4-O | Image of Flibanserin Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 26 January 2018

Zimmerman HJ. Antidepressants. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 493-8. (Expert review of hepatotoxicity of antidepressants published in 1999; flibanserin is not discussed).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 443-62. (Review of antidepressant hepatotoxicity; flibanserin is not discussed).
O'Donnell JM, Shelton RC. Drug therapy of depression and anxiety disorders. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 397-416. (Textbook of pharmacology and therapeutics: flibanserin is not discussed).
Drugs for female sexual dysfunction. Med Lett Drugs Ther 2010; 52 (1353-1354): 100-2. (Concise review of drugs for female sexual dysfunction including discussions of systemic estrogens, androgens, bupropion and topical agents and creams, mentions that flibanserin was reported to increase libido, but had worrisome side effects such as dizziness and fainting; no mention of ALT elevations or hepatotoxicity). 21150835
Moynihan R. Drug for low sexual desire carries significant harms, FDA advisers find. BMJ 2010; 341: c3339. (News report on the 2010 FDA advisory committee decision to not recommend approval of flibanserin mentions side effects of dizziness, somnolence and sedation, but does not mention ALT elevations or hepatotoxicity). 20610515
Stahl SM, Sommer B, Allers KA. Multifunctional pharmacology of flibanserin: possible mechanism of therapeutic action in hypoactive sexual desire disorder. J Sex Med 2011; 8: 15-27. (Review of the mechanism of action of flibanserin in enhancing female sexual desire through its mixed agonism and antagonism of different serotonin receptor subtypes). 20840530
Jayne C, Simon JA, Taylor LV, Kimura T, Lesko LM; SUNFLOWER study investigators. Open-label extension study of flibanserin in women with hypoactive sexual desire disorder. J Sex Med 2012; 9: 3180-8. (Among 1723 women treated with flibanserin for up to 12 months in an open label study in subjects who had completed a placebo-controlled trial of the agent, 11% discontinued the agent because of adverse events, mostly related to somnolence and dizziness, but “safety measures, including laboratory tests… did not show any clinically important findings”). 23057791
Derogatis LR, Komer L, Katz M, Moreau M, Kimura T, Garcia M Jr, Wunderlich G, et al.; VIOLET Trial Investigators. Treatment of hypoactive sexual desire disorder in premenopausal women: efficacy of flibanserin in the VIOLET Study. J Sex Med 2012; 9: 1074-85. (Among 880 premenopausal women with hypoactive sexual desire disorder treated with flibanserin [50 or 100 mg at bedtime] or placebo for 24 weeks, “clinically significant changes” in laboratory values did not occur more frequently with flibanserin than with placebo therapy; no mention of ALT elevations or hepatotoxicity). 22248038
Thorp J, Simon J, Dattani D, Taylor L, Kimura T, Garcia M Jr, Lesko L, et al.; DAISY trial investigators. Treatment of hypoactive sexual desire disorder in premenopausal women: efficacy of flibanserin in the DAISY study. J Sex Med 2012; 9: 793-804. (Among 1185 premenopausal women with hypoactive sexual desire syndrome treated with flibanserin [25, 50 or 100 mg at bedtime] or placebo for 24 weeks, sexual desire scores were higher in those who received 100 mg of flibanserin compared to placebo as were rates of discontinuations for adverse events, but “clinically significant changes” in laboratory values did not occur more frequently with flibanserin than placebo). 22239862
Park SH, Ishino R. Liver injury associated with antidepressants. Curr Drug Saf 2013; 8: 207-23. (Among 1087 premenopausal women with hypoactive sexual desire disorder treated with flibanserin [100 mg at bedtime] or placebo for 24 weeks, sexual desire measures improved more with flibanserin treatment and “there were no significant safety concerns”, the most frequent adverse events being somnolence [14%], dizziness [10%], nausea [8%] and fatigue [6%]; and “there were no clinically significant differences in laboratory” results between treatment groups). 23914755
Katz M, DeRogatis LR, Ackerman R, Hedges P, Lesko L, Garcia M Jr, Sand M; BEGONIA trial investigators. Efficacy of flibanserin in women with hypoactive sexual desire disorder: results from the BEGONIA trial. J Sex Med 2013; 10: 1807-15. . (Among 1087 premenopausal women with hypoactive sexual desire disorder treated with flibanserin or placebo for 24 weeks, adverse events were generally mild, and there were no treatment related serious adverse events and no "clinincally significant differences in laboratory parameters" between the 2 groups). 23672269
Simon JA, Kingsberg SA, Shumel B, Hanes V, Garcia M Jr, Sand M. Efficacy and safety of flibanserin in postmenopausal women with hypoactive sexual desire disorder: results of the SNOWDROP trial. Menopause 2014; 21: 633-40. (Among 949 postmenopausal women with hypoactive sexual desire disorder treated with flibanserin [100 mg at bedtime] or placebo for 24 weeks, subjective measures of sexual desire improved more with flibanserin than placebo, but adverse events were also more common resulting in discontinuation in 8%; no mention of changes or elevations in ALT levels or instances of hepatotoxicity). 24281236
Voican CS, Corruble E, Naveau S, Perlemuter G. Antidepressant-induced liver injury: a review for clinicians. Am J Psychiatry 2014; 171: 404-15. (Commentary by 3 members of the FDA advisory committee who reviewed the safety and efficacy data in support of flibanserin for hypoactive sexual desire disorder mentions the statistically significant, but numerically small treatment differences compared to placebo and the frequency of worrisome side effects such as hypotension, dizziness and sedation; no mention of ALT elevations or hepatotoxicity). 24362450
Gellad WF, Flynn KE, Alexander GC. Evaluation of flibanserin: science and advocacy at the FDA. JAMA 2015; 314: 869-70. (Commentary on the FDA decision to approve flibanserin and the possible roles of vocal advocacy groups, shifting efficacy end points, use of patient-reported outcome measures, the unmet medical need and the tenous risk-benefit ratio of the agent). 26148201
Jaspers L, Feys F, Bramer WM, Franco OH, Leusink P, Laan ET. Efficacy and safety of flibanserin for the treatment of hypoactive sexual desire disorder in women: a systematic review and meta-analysis. JAMA Intern Med 2016; 176: 453-62. (Systematic review of the efficacy and safety of flibanserin mentions severe adverse events of hypotension and syncope, but no mention of ALT elevations or hepatotoxicity). 26927498
Portman DJ, Brown L, Yuan J, Kissling R, Kingsberg SA. Flibanserin in postmenopausal women with hypoactive sexual desire disorder: results of the PLUMERIA Study. J Sex Med 2017; 14: 834-42. (Among 748 postmenopausal women with hypoactive sexual disorder treated with flibanserin or placebo for up to 16 weeks, common adverse events included insomnia [8% vs 3%], somnolence [7% vs 2%], dizziness [6% vs 4%] and nausea [5% vs 4%], and there were "no clinically relevant differences" in laboratory test results between the two groups). 28583342
Clayton AH, Croft HA, Yuan J, Brown L, Kissling R. Safety of Flibanserin in women treated With antidepressants: a randomized, placebo-controlled Study. J Sex Med 2018; 15: 43-51. (Among 111 women on antidepressant therapy who had symptoms of hypoactive sexual desire disorder and were treated with one of 2 dose regimens of flibanserin or placebo for 12 weeks, adverse events rates were similar in the different groups and there were no liver related severe adverse events and no mention of changes in ALT levels). 29289374

## OTHER REFERENCE LINKS

1. Recent References on Flibanserin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Flibanserin+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Flibanserin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Flibanserin)